# Axatilimab

## OVERVIEW

### Introduction

Axatilimab is a humanized monoclonal antibody to the colony stimulating factor-1 receptor that is used to treat patients with chronic graft-versus-host disease who have active disease despite having received at least two previous systemic therapies. Axatilimab therapy is often accompanied by transient serum enzyme elevations, but it has not been linked to instances of clinically apparent liver injury with jaundice.

### Background

Axatilimab (axe” a til’ i mab) is a humanized monoclonal IgG4 antibody directed against the colony stimulating factor-1 receptor (CSF-1R) which is used to treat adults with active, refractory chronic graft-vs-host disease (GvHD). Axatilimab binds to CSF-1R on monocytes and macrophages, blocking their activation and induction of proinflammatory cytokines and fibrogenic genes. This monoclonal antibody was shown to decrease disease activity in an animal model of GvHD. In human trials, axatilimab induced clinical responses in over 70% of patients with chronic GvHD who had received at least 2 previous systemic lines of therapy. Axatilimab was approved for use in the United States in 2024, the fourth agent approved for treatment of chronic GvHD, others being ibrutinib, belumosudil, and rituximab. Current indications for axatilimab are treatment of chronic GvHD despite at least previous systemic therapies in adults and pediatric patients weighing 40 kg or more. Axatilimab is available under the brand name Niktimvo in single dose vials of 50 mg in 1 mL. The recommended dose is 0.3 mg/kg body weight (maximal 35 mg) given as an intravenous infusion over 30 minutes every 2 weeks. Adverse effects can include infusion reactions for which premedication with an antihistamine and antipyretics is recommended in patients who experienced a previous infusion reaction to axatilimab. Other common adverse events include fatigue, musculoskeletal pain, headache, dizziness, nausea, diarrhea, cough, fever, dyspnea, and increased risk of bacterial, fungal and viral infections. Laboratory abnormalities can include elevations in liver enzymes, creatine kinase, amylase, lipase, and calcium, and decreases in hemoglobin and serum phosphate. Uncommon but potentially serious side effects include severe hypersensitivity reactions (angioedema or anaphylaxis), severe infections, and embryo-fetal toxicity.

### Hepatotoxicity

In preregistration controlled trials, elevations in serum aminotransferase levels arose in 12.7% of patients treated with 0.3 mg/kg and in higher rates with higher doses, 21.5% at 1 mg/kg and 40% at 3 mg/kg. Elevations in aminotransferase levels above 5 times the ULN occurred in only 1.3% of patients and all of the elevations were transient and none required drug discontinuation or was accompanied by jaundice. Since its approval, there have been no case reports of liver injury with jaundice linked to axatilimab therapy but clinical experience with the drug has been limited. Furthermore, patients with chronic GvHD frequently have elevations in serum enzymes because of graft-vs-host injury to the liver. Reactivation of hepatitis B as well as immune-mediated hepatitis can occur with use of immunosuppressive monoclonal antibodies such as infliximab and adalimumab, but instances have not been reported with axatilimab.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Serum ALT elevations may be a direct result of inhibition of CSF-1R because elevations occur in many enzyme levels including alkaline phosphatase, GGT, creatine phosphatase, amylase and lipase, but rarely result in organ injury. These transient laboratory abnormalities may be explained by Kupffer cells depletion and reduced clearance function following CSF-1R blockade. Graft-vs-host disease commonly affects the liver, and liver test abnormalities during axatilimab therapy may be due to the underlying disease rather than the drug therapy. For this reason, patients should be assessed for the presence of liver involvement before starting therapy for chronic GvHD.

### Outcome and Management

It is appropriate to monitor patients with chronic GvHD for liver test abnormalities before starting and at intervals during therapy. The serum aminotransferase elevations that were reported during axatilimab therapy were generally transient, mild and asymptomatic and did not require dose modification or delay in therapy. Elevations above 5 times the upper limit of normal should lead to clinical assessment of the possible causes and more careful monitoring and suspension of further infusions, at least until levels return to normal or near normal levels or until the underlying cause is identified. There is no evidence of cross sensitivity to hepatic reactions among the various monoclonal antibodies or small molecule therapies for GvHD.

Drug Class: Monoclonal Antibodies

Other Drugs for GvHD: Belumosudil, Ibrutinib, Ruxolitinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Axatilimab – Niktimvo®

DRUG CLASS

Immunosuppressive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Axatilimab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Axatilimab | 2155851-88-8 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 07 November 2024

Abbreviations: CSF-1R, colony stimulating factor-1 receptor; GvHD, graft-vs-host disease.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents before the availability of axatilimab).
Krensky AM, Azzi JR, Hafler DA. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 637-53. (Textbook of pharmacology and therapeutics).
FDA. Multi-Discipline Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/761411Orig1s000TOC.cfm (FDA website with product labels and initial multidiscipline clinical review of the safety and efficacy of axatilimab based on results from registration trials in support of its approval as therapy of chronic graft-vs-host disease [GvHD] mentions that in the safety cohort of 279 patients treated with axatilimab, ALT elevations arose in 12.7% of patients on 0.3 mg/kg, 21.5% on 1 mg/kg, and 40% on 3 mg/kg and values rose above 5 times ULN in 1.3%, 1.9% and 2.5%, but there were no ALT elevations with jaundice or serious hepatic adverse events).
Kitko CL, Arora M, DeFilipp Z, Zaid MA, Di Stasi A, Radojcic V, Betts CB, et al. Axatilimab for chronic graft-versus-host disease after failure of at least two prior systemic therapies: results of a phase I/II study. J Clin Oncol. 2023;41:1864-1875. (Among 40 patients 6 years of age or older with active, chronic GvHD after at least 2 systemic lines of therapy treated with varying doses of axatilimab intravenously every 4 weeks, the overall response rate was 80% and dose limiting toxicities included myopathy and pancreatitis; and while ALT, AST, Alk P, lipase, and amylase elevations were frequent they were without end-organ damage). 36459673
Wolff D, Cutler C, Lee SJ, Pusic I, Bittencourt H, White J, Hamadani M, et al.; AGAVE-201 Investigators. Axatilimab in recurrent or refractory chronic graft-versus-host disease. N Engl J Med. 2024;391:1002-1014. (Among 241 adults with active, chronic GvHD after at least 2 systemic lines of therapy who were treated with 0.3, 1 or 3 mg/kg intravenously every 2 weeks, the overall response rate was 74%, 67%, and 50% and adverse events were more frequent and severe with higher doses, and ALT elevations arose in 13%, 22%, and 39%, and drug discontinuation for adverse events occurred in 6%, 22%, and 18% of patients). 39292927
Sarantopoulos S. Targeting CSF1R in chronic GVHD – lessons in translation. N Engl J Med. 2024;391:1053-1055. (Editorial in response to Wolff [2024] providing the background to the development of therapies targeting CSF1, which acts on its receptor on monocytes and macrophages leading to secretion of proinflammatory cytokines and profibrotic effects that account for some of the chronic tissue damage in GvHD and the inhibition of which led to improvements in disease in a mouse model). 39292932
Mohty M. CSF1R blockade for refractory chronic graft-versus-host disease. N Engl J Med. 2024;391:1055-1059. (Brief review of the clinical features and pathophysiology of GvHD and the role of CSF1R in its chronic complications). 39292933

## OTHER REFERENCE LINKS

1. Recent References on Axatilimab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Axatilimab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Axatilimab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Axatilimab)